# Bendamustine

## OVERVIEW

### Introduction

Bendamustine is a parenterally administered alkylating agent used alone and in combination with other antineoplastic agents in the treatment of chronic lymphocytic leukemia and refractory forms of non-Hodgkin lymphoma. Bendamustine therapy is associated with minor transient serum enzyme elevations during treatment and to rare instances of clinically apparent liver injury, with jaundice generally arising as a part of a generalized hypersensitivity syndrome. Bendamustine also has potent immunosuppressive activity and can cause reactivation of chronic hepatitis B that can be severe and even fatal.

### Background

Bendamustine (ben" da mus' teen) is a relatively novel alkylating agent with a benzimidazole ring giving it purine analogue-like properties. Like other alkylating agents, bendamustine is thought to act by modifying and cross linking purine bases in DNA, thus inhibiting DNA, RNA and protein synthesis and leading to cell death in rapidly dividing cells. Bendamustine appears to have a special activity against B cell leukemias and lymphomas. Bendamustine was approved for use in the United States in 2008 as therapy for chronic lymphocytic leukemia, and indications were later expanded to include indolent B cell non-Hodgkin lymphoma that is refractory to rituximab containing regimens. Bendamustine is given intravenously and is available in liquid formulations (45 and 180 mg vials: 90 mg/mL) and as powder for reconstitution (25 or 100 mg in a single use vial) generically and under the trade name Treanda. Recommended doses vary by age, body weight and malignant condition. Bendamustine is often given in combination with other antineoplastic agents on days 1 and 2 of 21- or 28-day cycles. The toxicity of bendamustine is similar to that of other alkylating agents. Common side effects include bone marrow suppression, nausea, vomiting, diarrhea, anorexia, fatigue, dizziness and hypersensitivity rashes. Serious adverse events include severe myelosuppression, bacterial infections, infusion reactions, local extravasation injury, anaphylaxis, tumor lysis syndrome and Stevens Johnson syndrome.

### Hepatotoxicity

Mild and transient elevations in serum aminotransferase levels are found in up to 20% of patients treated with bendamustine, but elevations above 5 times the upper limit of normal occur in less than 3% of patients. The abnormalities are generally transient, unaccompanied by symptoms and rarely require dose modification. Clinically apparent liver injury from bendamustine has been limited to a small number of cases of mild hepatitis with features of hypersensitivity including eosinophilia, rash or other systemic symptoms. Autoantibody formation is uncommon. The course is generally self-limited, but may require corticosteroid therapy for control of symptoms and timely recovery.

Bendamustine therapy has also been implicated in causing reactivation of hepatitis B in patients with anti-HBc in serum with or without HBsAg. In several instances patients were also receiving corticosteroids or rituximab, yet had received these without reactivation in the past. Reactivation arose after 2 to 6 cycles of bendamustine chemotherapy, presenting with symptoms accompanied by HBsAg and rising levels of HBV DNA in serum. Reactivation was generally self-limited and patients later became HBsAg negative. In one instance, however, the course was severe and resulted in death from acute liver failure.

Likelihood score: C (probable cause of clinically apparent liver injury, some of which is due to reactivation of hepatitis B).

### Mechanism of Injury

The mild serum aminotransferase elevations that occur with bendamustine therapy are most likely due to direct hepatotoxicity and are generally mild, asymptomatic and resolve without dose modification or intervention. The more clinically apparent forms of bendamustine hepatotoxicity are likely due to hypersensitivity. Bendamustine is rarely used in myeloablative regimens in preparation of hematopoietic cell transplantation and has not been linked to cases of sinusoidal obstruction syndrome, although in high enough doses it is likely to cause sinusoidal cell injury as do other alkylating agents. Bendamustine also appears to be capable of causing reactivation of hepatitis B, probably because of its potent immunosuppressive activity. Bendamustine is extensively metabolized by the hepatic cytochrome P450 system, predominantly CYP 1A2, and may be susceptible to drug-drug interactions with agents that induce or inhibit CYP 1A2 activity.

### Outcome and Management

The severity of liver injury from bendamustine ranges from mild elevations in liver enzymes to anicteric, but symptomatic hepatitis to clinically apparent hepatitis with jaundice. Monitoring of liver tests during therapy is recommended. Cases of acute liver failure, chronic hepatitis or vanishing bile duct syndrome have not been reported. Patients with hypersensitivity reactions to bendamustine should not be reexposed to the agent. There is no information on the cross reactivity of hypersensitivity reactions to bendamustine with other alkylating agents such as mechlorethamine (nitrogen mustard), carmustine (CCNU), lomustine (BCNU), chlorambucil and cyclophosphamde. Because bendamustine can cause reactivation of hepatitis B, patients should be screened for HBsAg and anti-HBc before starting therapy and either offered prophylaxis with agents active against hepatitis B (entecavir, tenofovir) or monitored closely for HBV DNA levels and started on therapy if viral titers rise.

Drug Class: Antineoplastic Agents, Alkylating Agents

## CASE REPORT

### Case 1. Acute hypersensitivity reaction with hepatitis attributed to bendamustine

[Modified from: Jo T, Horio K. Severe liver damage and nonallergic bronchitis with eosinophilia in a patient with follicular lymphoma treated with bendamustine plus rituximab. Case Rep Oncol 2014; 7: 497-502. PubMed Citation (https://www.ncbi.nlm.nih.gov/pubmed/25232317)].

A 66 year old woman with follicular lymphoma developed cough and liver test abnormalities 16 days after starting an initial cycle of bendamustine and rituximab. She had the recent diagnosis of stage IIIa follicular lymphoma with multiple lymph node involvement. After a first course of R-CHOP therapy, she refused further courses because of peripheral neuropathy, alopecia and fatigue. For these reasons, she was switched to rituximab (375 mg/m^2^ on day 1) and bendamustine (75 mg/m^2^ on days 2 and 3 of planned 21 day cycles). She developed a severe cough that caused insomnia and fatigue and was found to have bronchitis and liver test abnormalities with ALT 93 U/L, AST 133 U/L, alkaline phosphatase 274 U/L and bilirubin 0.7 mg/dL. She had no history of smoking, drug allergies or know exposure to hepatitis. Tests for acute hepatitis A, B and C were negative as were assays for CMV and mycoplasma infection. Imaging of the liver was normal and a CT scan of the chest showed no evidence of pneumonitis. Her cough continued, but cultures were negative and she was evidently afebrile. At the same time liver tests worsened; serum bilirubin rising to 6.2 mg/dL, ALT to 577 U/L and alkaline phosphatase to 932 U/L (Table). Peripheral eosinophil counts, that had been normal initially, began to rise (peaking at 36%). Because of worsening symptoms and laboratory test results suggesting a hypersensitivity reaction, she was treated with a short course of high dose methylprednisolone and improved rapidly. She was switched to oral prednisone which was gradually reduced in dose and then discontinued. In follow up, her cough resolved and liver tests were normal. Bendamustine was not restarted.

#### Key Points

Medication: | Bendamustine (2 doses of 75 mg/m^2^ intravenously)
Pattern: | Mixed (R=~4.5)
Severity: | 3+ (jaundice, hospitalized)
Latency: | 2 weeks
Recovery: | Within 2 months (incomplete)
Other medications: | Rituximab, no other mediations mentioned

#### Laboratory Values

Time After Starting | Time After Stopping | ALT (U/L) | Alk P (U/L) | Eosinophils (%) | Bilirubin (mg/dL) | Other
Pre (-2 days) | 0 | 12 | 285 | 3% | 0.6
Day 1 | 0 | | | | | iv rituximab
Day 2-3 | 0 | | | | | iv bendamustine
9 days | 7 days | 12 | 268 | 7% | 2.9
16 days | 14 days | 93 | 274 | 1% | 0.7 | Cough and fatigue
28 days | 26 days | 477 | 947 | 2% | 1.4 | Admission
31 days | 29 days | 557 | 932 | 18% | 3.1 | GGT 422 U/L
34 days | 32 days | 577 | 900 | 19% | 5.6
41 days | 39 days | 466 | 731 | 36% | 6.2
44 days | 42 days | 365 | 693 | 34% | 4.5 | Methylprednisolone
50 days | 7 weeks | 73 | 409 | 5% | 2.2 | Prednisone
58 days | 8 weeks | 23 | 266 | 2% | 1.1 | Prednisone
64 days | 9 weeks | 16 | 250 | 1% | 1.2
90 days | 3 months | 13 | 242 | 0% | 1.0
Normal Values (est.) | | <40 | <280 | <5% | <1.2

#### Comment

A woman with follicular lymphoma developed a hypersensitivity reaction within 2 weeks of starting an initial cycle of rituximab and bendamustine. The major symptoms were cough and fatigue which appeared to be due to an allergic bronchitis. Accompanying this was a mild hepatitis that nevertheless progressed to jaundice and was accompanied by a rising eosinophilia. Treatment with corticosteroids rapidly brought the hypersensitivity reaction under control and her liver tests were normal within 4 to 6 weeks and remained normal even with tapering and discontinuation of corticosteroids. There was evidently no rash or fever, so that the reaction is best described as “drug-hypersensitivity with systemic symptoms” rather than DRESS syndrome. One might hypothesize that rituximab altered the clinical expression of the hypersensitivity reaction. Hypersensitivity reactions (usually rash) are not infrequent with bendamustine therapy (1% to 4%) but are generally mild and self-limited, although rare instances of Stevens Johnson syndrome have been reported.

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Bendamustine – Treanda®

DRUG CLASS

Antineoplastic Agents, Alkylating Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Bendamustine)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Bendamustine | 3543-75-7 | C16-H21-Cl2-N3-O2.Cl-H | Bendamustine chemical structure

## ANNOTATED BIBLIOGRAPHY

References updated: 01 September 2017

Zimmerman HJ. Oncotherapeutic and immunosuppressive agents. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 673-708. (Expert review of hepatotoxicity of cancer chemotherapeutic agents published in 1999, before the availability of bendamustine).
DeLeve LD. Cancer chemotherapy. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 541-68. (Review of hepatotoxicity of cancer chemotherapeutic agents; no mention of bendamustine).
Chabner BA, Bertino J, Clearly J, Ortiz T, Lane A, Supko JG, Ryan DP. Cytotoxic agents. Chemotherapy of neoplastic diseases. In, Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, pp. 1677-730. (Textbook of pharmacology and therapeutics).
Friedberg JW, Cohen P, Chen L, Robinson KS, Forero-Torres A, La Casce AS, Fayad LE, et al. Bendamustine in patients with rituximab-refractory indolent and transformed non-Hodgkin's lymphoma: results from a phase II multicenter, single-agent study. J Clin Oncol 2008; 26: 204-10. (Among 76 patients with refractory non-Hodgkin lymphoma treated with bendamustine monotherapy [days 1 and 2 in 21 day cycles], the overall response rate was 77% and adverse events were common, but ALT elevations and hepatotoxicity were not mentioned). 18182663
Knauf WU, Lissichkov T, Aldaoud A, Liberati A, Loscertales J, Herbrecht R, Juliusson G, et al. Phase III randomized study of bendamustine compared with chlorambucil in previously untreated patients with chronic lymphocytic leukemia. J Clin Oncol 2009; 27: 4378-84. (Among 319 patients with chronic lymphocytic leukemia treated with bendamustine [iv on days 1 and 2] or chlorambucil [orally] in 28 day cycles for up to 6 months, the complete response rate was higher with bendamustine [31% vs 2%], but side effects were also more common; no mention of ALT elevations or hepatotoxicity). 19652068
Kahl BS, Bartlett NL, Leonard JP, Chen L, Ganjoo K, Williams ME, Czuczman MS, et al. Bendamustine is effective therapy in patients with rituximab-refractory, indolent B-cell non-Hodgkin lymphoma: results from a Multicenter Study. Cancer 2010; 116: 106-14. (Among 100 patients with refractory B cell lymphoma treated with bendamustine [iv on days 1 and 2 in 6 to 8 21-day cycles], the overall response rate was 75% and side effects were common and included 39 serious adverse events and 7 deaths, but none were attributed to liver injury). 19890959
Alamdari HS, Pinter-Brown L, Cassarino DS, Chiu MW. Severe cutaneous interface drug eruption associated with bendamustine. Dermatol Online J 2010; 16: 1. (75 year old man with B cell lymphoma developed diffuse erythematous desquamating rash 5 days after a second course of bendamustine which responded slowly to prednisone therapy; no mention of liver test abnormalities). 20673529
Cheson BD, Friedberg JW, Kahl BS, Van der Jagt RH, Tremmel L. Bendamustine produces durable responses with an acceptable safety profile in patients with rituximab-refractory indolent non-Hodgkin lymphoma. Clin Lymphoma Myeloma Leuk 2010; 10: 452-7. (Among 161 patients with rituximab-refractory indolent non-Hodgkin lymphoma treated with bendamustine in two open labelled trials [Kahl 2010 & Freiberg 2008], the overall and complete response rates were 76% and 23%, but side effects were common including hematologic [~94%], febrile neutropenia [11%], nausea [75%], infection [61%], fatigue [57%], diarrhea [39%], anorexia [23%] and secondary malignancies [5%]; no mention of ALT elevations or hepatotoxicity). 21189660
Tapan U, May SK, Fiore J, Kozyreva O. Reactivation of hepatitis B virus following bendamustine-containing chemotherapy in a patient with multiple myeloma. Leuk Lymphoma 2011; 52: 916-8. (64 year old man with myeloma developed reactivation of hepatitis B after two cycles of bendamustine and dexamethasone [bilirubin 10.1 mg/dL, ALT 1759 U/L, Alk P 85 U/L, INR 1.6, HBV DNA 8.7 million IU/mL, HBsAg positive], dying one month later despite entecavir therapy and HBV DNA decline to 400 IU/mL]). 21306291
Lock G, Helmich F, Bertram M. [Impending liver failure after chemoimmunotherapy-induced reactivation of hepatitis B - successful treatment with entecavir]. Dtsch Med Wochenschr 2012; 137: 1248-50. (83 year old woman with leukemia developed acute reactivation of hepatitis B after 6 cycles of bendamustine and rituximab [bilirubin 27.8 mg/dL, ALT 1353 U/L, INR 1.7, HBV DNA 1.6 million IU/mL, HBsAg positive], resolving with entecavir therapy and later becoming HBsAg negative and anti-HBs positive). 22644491
Tsutsumi Y, Ogasawara R, Miyashita N, Tanaka J, Asaka M, Imamura M. HBV reactivation in malignant lymphoma patients treated with rituximab and bendamustine. Int J Hematol 2012; 95: 588-91. (79 and 53 year old women, with multiple previous courses of rituximab and CHOP and anti-HBc without HBsAg in serum, developed reactivation of hepatitis B after 2 and 4 courses of bendamustine and rituximab [mild symptoms, bilirubin not given, ALT 340 and 68 U/L, HBV DNA 3.7 and 8.8 log copies/mL and HBsAg in serum], both resolving with entecavir therapy). 22419099
Rago A, Ridola L, Lichtner M, Mecarocci S, Marocco R, Cenfra N, Belvisi V, et al. Hepatitis B reactivation despite entecavir prophylaxis in a patient with chronic lymphocytic leukaemia receiving bendamustine. J Antimicrob Chemother 2012; 67: 510-1. (Patient with CLL and HBsAg in serum [HBV DNA negative] was started on bendamustine and given prophylactic entecavir but nevertheless developed rising levels of HBV DNA [1.3 million IU/mL] and mild enzyme elevations [ALT 73 U/L], which responded to adding tenofovir and using higher doses of entecavir; patient later tolerated chemotherapy without further evidence of reactivation). 22110085
Fischer K, Cramer P, Busch R, Böttcher S, Bahlo J, Schubert J, Pflüger KH, et al. Bendamustine in combination with rituximab for previously untreated patients with chronic lymphocytic leukemia: a multicenter phase II trial of the German Chronic Lymphocytic Leukemia Study Group. J Clin Oncol 2012; 30: 3209-16. (Among 117 patients with previously untreated chronic lymphocytic leukemia treated with bendamustine and rituximab in 21 day courses, response rates were 88% overall of which 23% were complete, and side effects included severe hematologic adverse events in 27%, infections in 8% and allergic reactions in 9%; no mention of ALT elevations or hepatotoxicity). 22869884
Ohmachi K, Niitsu N, Uchida T, Kim SJ, Ando K, Takahashi N, Takahashi N, et al. Multicenter phase II study of bendamustine plus rituximab in patients with relapsed or refractory diffuse large B-cell lymphoma. J Clin Oncol 2013; 31: 2103-9. (Among 59 patients with refractory B cell lymphoma treated with bendamustine [days 2 and 3] and rituximab [day 1] in 21 day cycles, the overall response rate was 63% and side effects were common, both hematologic and nonhematologic; no mention of ALT elevations or hepatotoxicity). 23650408
Rummel MJ, Niederle N, Maschmeyer G, Banat GA, von Grünhagen U, Losem C, Kofahl-Krause D, et al.; Study group indolent Lymphomas (StiL). Bendamustine plus rituximab versus CHOP plus rituximab as first-line treatment for patients with indolent and mantle-cell lymphomas: an open-label, multicentre, randomised, phase 3 non-inferiority trial. Lancet 2013; 381 (9873): 1203-10. (Among 549 patients with previously untreated indolent mantel cell lymphomas treated with rituximab and either bendamustine or CHOP, bendamustine had lower rates of severe hematologic toxicity, alopecia, stomatitis, infections and neuropathies but more cases of rash; no mention of ALT elevations or hepatotoxicity). 23433739
Jo T, Horio K. Severe liver damage and nonallergic bronchitis with eosinophilia in a patient with follicular lymphoma treated with bendamustine plus rituximab. Case Rep Oncol 2014; 7: 497-502. (66 year old woman with follicular lymphoma developed liver test abnormalities 16 days after receiving a first cycle of bendamustine and rituximab [bilirubin rising from 0.7 to 6.2 mg/dL, ALT 133 to 557 U/L, Alk P 274 to 947 U/L], with eosinophilia and bronchitis, resolving within 3 weeks on prednisone therapy: Case 1). 25232317
Flinn IW, van der Jagt R, Kahl BS, Wood P, Hawkins TE, Macdonald D, Hertzberg M, et al. Randomized trial of bendamustine-rituximab or R-CHOP/R-CVP in first-line treatment of indolent NHL or MCL: the BRIGHT study. Blood 2014; 123: 2944-52. (Among 447 patients with indolent non-Hodgkin or mantle cell leukemia treated with up to 6 cycles of either bendamustine with rituximab or standard therapy [R-CHOP or R-CVP], overall response rates were 97% vs 91% and complete response 31% vs 25%; side effects of nausea, vomiting and hypersensitivity were more common with bendamustine and alopecia and neuropathies less frequent; most common reasons for discontinuing bendamustine were neutropenia, thrombocytopenia and rash; no mention of ALT elevations or hepatotoxicity). 24591201
Cortelezzi A, Sciumè M, Liberati AM, Vincenti D, Cuneo A, Reda G, Laurenti L, et al. Bendamustine in combination with ofatumumab in relapsed or refractory chronic lymphocytic leukemia: a GIMEMA Multicenter Phase II Trial. Leukemia 2014; 28: 642-8. (Among 47 patients with refractory chronic lymphocytic leukemia treated with up to six 28-day cycles of bendamustine and ofatumumab, response rates were 72% overall of which 17% were complete, and severe adverse events were largely hematologic, with severe infections in 6%, tumor lysis syndrome in 4%, but no ALT or AST elevations above 5 times ULN). 24220274
Czuczman MS, Goy A, Lamonica D, Graf DA, Munteanu MC, van der Jagt RH. Phase II study of bendamustine combined with rituximab in relapsed/refractory mantle cell lymphoma: efficacy, tolerability, and safety findings. Ann Hematol 2015; 94: 2025-32. (Among 45 patients with refractory mantle cell lymphoma treated with bendamustine and rituximab in 28 day cycles, response rates were 82% overall [40% complete] and adverse events included nausea [69%], fatigue [57%], anorexia [42%], severe infections [16%], but there were no liver related severe adverse events, discontinuations or deaths). 26411584
Kouroukis CT, Crump M, MacDonald D, Larouche JF, Stewart DA, Johnston J, Sauvageau S, et al. An open-label expanded-access trial of bendamustine in patients with rituximab-refractory indolent non-Hodgkin lymphoma or previously untreated chronic lymphocytic leukemia: BEND-ACT. Curr Oncol 2015; 22: 260-71. (Among 90 patients with rituximab refractory chronic lymphocytic leukemia or non-Hodgkin lymphoma treated with bendamustine in 21 or 28 day cycles, side effects included nausea [70%], fatigue [57%], diarrhea [33%], myelosuppression, febrile neutropenia [6%] and tumor lysis syndrome [2%], but there no liver related severe adverse events, discontinuations or deaths). 26300664
Luminari S, Goldaniga M, Cesaretti M, Orsucci L, Tucci A, Pulsoni A, Salvi F, et al. A phase II study of bendamustine in combination with rituximab as initial treatment for patients with indolent non-follicular non-Hodgkin lymphoma. Leuk Lymphoma 2016; 57: 880-7. (Among 65 patients with advanced, indolent non-Hodgkin lymphoma treated with bendamustine and rituximab in 28 day cycles, the response rate was 86% overall [complete in 48%] and serious adverse events were largely hematologic and 3% developed febrile neutropenia; no mention of ALT elevations or hepatotoxicity). 26379040
Gentile M, Zirlik K, Ciolli S, Mauro FR, Di Renzo N, Mastrullo L, Angrilli F, et al. Combination of bendamustine and rituximab as front-line therapy for patients with chronic lymphocytic leukaemia: multicenter, retrospective clinical practice experience with 279 cases outside of controlled clinical trials. Eur J Cancer 2016; 60: 154-65. (Retrospective analysis of 279 patients with chronic lymphocytic leukemia treated with 1 to 6 28-day cycles of bendamustine and rituximab found an overall response rate of 86% [25% complete] and severe adverse event rate of 41%, neutropenia 28%, infections 8.6% and rash 5.1%; among 10 patients who died one died of fulminant hepatitis, but no details given). 27127905
Rummel M, Kaiser U, Balser C, Stauch M, Brugger W, Welslau M, Niederle N, et al.; Study Group Indolent Lymphomas. Bendamustine plus rituximab versus fludarabine plus rituximab for patients with relapsed indolent and mantle-cell lymphomas: a multicentre, randomised, open-label, non-inferiority phase 3 trial. Lancet Oncol 2016; 17: 57-66. (Among 219 patients with relapsed indolent or mantle cell lymphomas treated with rituximab and either bendamustine or fludarabine in up to 6 28-day cycles, overall response rates were higher with bendamustine [82% vs 54%] as were complete responses [40% vs 18%], while side effect rates were similar; ALT or AST elevations occurred in 19% vs 9%, but were less than 3 times ULN in all; one patient receiving rituximab and fludarabine developed “toxic hepatitis”, but no details given). 26655425
Flinn IW, Panayiotidis P, Afanasyev B, Janssens A, Grosicki S, Homenda W, Smolej L, et al. A phase 2, multicenter study investigating ofatumumab and bendamustine combination in patients with untreated or relapsed CLL. Am J Hematol 2016; 91: 900-6. (Among 44 patients with previously untreated and 53 with refractory chronic lymphocytic leukemia treated with bendamustine and ofatumumab in 2 to 6 28-day cycles, the overall response rate was 95% and 74% [complete in 43% and 11%] and “no unexpected toxicities were reported”). 27222473

## OTHER REFERENCE LINKS

1. Recent References on Bendamustine: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Bendamustine+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Bendamustine: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Bendamustine)